# Metiglinide Analogues

## OVERVIEW

Metiglinide analogues are insulin secretagogues that are structurally unrelated to the sulfonylureas, but share a similar mechanism of action. These compounds are named for the initial, prototype molecule, metiglinide, found to have a sulfonylurea-like effect in stimulating the pancreatic beta cell to secret insulin. Metiglinides have been found to improve postprandial hyperglycemia in diabetic patients and to improve glycemic control and hemoglobin A1c levels. Two metiglinides have been approved for use in the United States: repaglinide in 1997 and nateglinide in 2000. Both are now available generically as well as under the initial brand names of Prandin and Starlix. These agents are generally used in combination with other oral hypoglycemic agents and, because they rely upon stimulation of beta cells, are useful only in type 2 diabetes. Repaglinide and nateglinide are generally well tolerated. Common side effects include diarrhea, nausea, dizziness, headache, malaise and hypoglycemia. Repaglinide has been implicated in several instances of clinically apparent liver injury which have been reported in the literature. Nateglinide has been available for a shorter period of time and, while not the subject of published cases, is said to have been linked to cases of hepatitis and jaundice in the product label.

References to the safety and potential hepatic injury associated with these agents are given together after this introductory section.

The following links are to individual drug records.

- Nateglinide
- Repaglinide

Drug Class: Antidiabetic Agents

## ANNOTATED BIBLIOGRAPHY

References updated: 21 May 2018

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 575-9. (Textbook of hepatotoxicity published in 1999; does not mention nateglinide or repaglinide).
De Marzio DH, Navarro VJ. Alpha-glucosidase inhibitors. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 529-30. (Review of hepatotoxicity of drugs for diabetes mentions that repaglinide has been implicated in two cases of cholestatic hepatitis, but nateglinide has yet to be linked to hepatic injury).
Powers AC, D'Alessio D. Therapy of diabetes. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1248-67. (Textbook of pharmacology and therapeutics).
Davis SN. Insulin, oral hypoglycemic agents, and the pharmacology of the endocrine pancreas. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 1613-88. (Textbook of pharmacology and therapeutics).
Schatz H. Preclinical and clinical studies on safety and tolerability of repaglinide. Exp Clin Endocrinol Diabetes 1999; 107 Suppl 4: S144-8. (In premarketing studies of repaglinide representing at least 1200 patient years, no serious hepatic events arose, allergic reactions were rare, and there were "no clinically relevant changes in liver enzymes"). 10522841
Marbury T, Huang WC, Strange P, Lebovitz H. Repaglinide versus glyburide: a one-year comparison trial. Diabetes Res Clin Pract 1999; 43: 155-66. (Among 575 patients with type 2 diabetes randomized to receive repaglinide or glyburide for up to 1 year, adverse events were similar with both drugs; no mention of ALT elevations or hepatotoxicity). 10369424
Wolffenbuttel BH, Landgraf R. A 1-year multicenter randomized double-blind comparison of repaglinide and glyburide for the treatment of type 2 diabetes. Dutch and German Repaglinide Study Group. Diabetes Care 1999; 22: 463-7. (Controlled trial of repaglinide vs glyburide in 424 patients with diabetes treated for 1 year; minor hypoglycemic episodes occurred in 9% of both groups; no mention of changes in ALT or liver toxicity). 10097930
Hanefeld M, Bouter KP, Dickinson S, Guitard C. Rapid and short-acting mealtime insulin secretion with nateglinide controls both prandial and mean glycemia. Diabetes Care 2000; 23: 202-7. (Controlled trial of 4 doses of nateglinide vs placebo for 12 weeks in 289 patients with diabetes showing improvements in postprandial glucose and insulin levels; one patient on nateglinide had elevations in ALT and GGT that resolved promptly on stopping). 10868832
Jovanovic L, Dailey G 3rd, Huang WC, Strange P, Goldstein BJ. Repaglinide in type 2 diabetes: a 24-week, fixed-dose efficacy and safety study. J Clin Pharmacol 2000; 40: 49-57. (Controlled trial of 24 weeks of repaglinide vs placebo in 361 patients with diabetes; side effects included headache, diarrhea, nausea and hypoglycemia; no hepatic side effects mentioned). 10631622
Madsbad S, Kilhovd B, Lager I, Mustajoki P, Dejgaard A; Scandinavian Repaglinide Group. Comparison between repaglinide and glipizide in Type 2 diabetes mellitus: a 1-year multicentre study. Diabet Med 2001; 18: 395-401. (Controlled trial of 1 year course of repaglinide vs glipizide in 256 patients with diabetes; mean serum Alk P and AST levels decreased in the repaglinide and increased in the glipizide treated groups; no clinically apparent liver injury). 11472451
Halas CJ. Nateglinide. Am J Health Syst Pharm 2001; 58: 1200-5. (Review of the pharmacology, clinical efficacy and safety of nateglinide; side effects are usually mild to moderate; one patient developed elevations in serum liver enzymes which returned to normal upon stopping). 11449877
Chitturi S, George J. Hepatotoxicity of commonly used drugs: nonsteroidal anti-inflammatory drugs, antihypertensives, antidiabetic agents, anticonvulsants, lipid-lowering agents, psychotropic drugs. Semin Liver Dis 2002; 22: 169-83. (Overview of hepatotoxicity of antidiabetic medications; the metiglinides are not discussed). 12016548
Schatz H, Schoppel K, Lehwalder D, Schandry R. Efficacy, tolerability and safety of nateglinide in combination with metformin. Results from a study under general practice conditions. Exp Clin Endocrinol Diabetes 2003; 111: 262-6. (Postmarketing surveillance study of addition of nateglinide to standard diabetes therapy in 11,476 patients; adverse events were reported in 2.9%, no serious liver complications reported). 12951631
Rosenstock J, Hassman DR, Madder RD, Brazinsky SA, Farrell J, Khutoryansky N, Hale PM; Repaglinide Versus Nateglinide Comparison Study Group. Repaglinide versus nateglinide monotherapy: a randomized, multicenter study. Diabetes Care 2004; 27: 1265-70. (Controlled trial of 16 weeks of repaglinide vs nateglinide in 150 patients with diabetes; there were "no notable differences in the patterns of adverse events for the two treatment groups"). 15161773
Nan DN, Hernández JL, Fernández-Ayala M, Carrascosa M. Acute hepatotoxicity caused by repaglinide. Ann Intern Med 2004; 141: 823. (70 year old man developed jaundice 2 weeks after starting repaglinide [bilirubin 13.2 mg/dL, ALT 115 U/L, Alk P 506 U/L, no eosinophilia], resolving within 2 months of stopping). 15545689
López-García F, Borrás J, Verdú C, Salazar VR, Ruiz JA, Sales J, Lucena MI, et al. Cholestatic hepatitis associated with repaglinide. Diabetes Care 2005; 28: 752-3. (72 year old man developed jaundice and itching 6 weeks after starting repaglinide [bilirubin 12.2 mg/dL, ALT 183 U/L, Alk P 307 U/L], resolving within 4 weeks of stopping). 15735221
Morita Y, Ueno T, Sasaki N, Tateishi Y, Nagata E, Kage M, Sata M. Nateglinide is useful for nonalcoholic steatohepatitis(NASH) patients with type 2 diabetes. Hepatogastroenterology 2005; 52: 338-43. (Ten patients with diabetes and nonalcoholic steatohepatitis were treated with nateglinide [270 mg/day] or followed on no treatment for 20 weeks; serum ALT levels decreased [31 to 23 U/L] and histology improved significantly in nateglinide treated patients; control subjects also improved, but not significantly). 16201069
Gerich J, Raskin P, Jean-Louis L, Purkayastha D, Baron MA. PRESERVE-beta: two-year efficacy and safety of initial combination therapy with nateglinide or glyburide plus metformin. Diabetes Care 2005; 28: 2093-9. (Controlled trial of two years of nateglinide vs glyburide added to metformin in 428 patients with diabetes; two arms had similar glycemic control and similar rates of side effects and no liver related adverse events reported). 16123472
Papa G, Fedele V, Rizzo MR, Fioravanti M, Leotta C, Solerte SB, Purrello F, et al. Safety of type 2 diabetes treatment with repaglinide compared with glibenclamide in elderly people: A randomized, open-label, two-period, cross-over trial. Diabetes Care 2006; 29: 1918-20. (Controlled trial of 24 weeks of repaglinide vs glyburide in 88 elderly patients with diabetes; "there were no significant changes between treatments for other clinical and laboratory parameters"). 16873803
Marshall V, Wilton L, Shakir S. Safety profile of repaglinide as used in general practice in England: results of a prescription-event monitoring study. Acta Diabetol 2006; 43: 6-13. (Postmarketing survey of adverse events occurring in 6651 patients treated with repaglinide by general practitioners in the UK; most common side effects reported were diarrhea, abdominal pain, nausea, headache and dizziness; 5 instances of elevated liver enzymes, but no jaundice or clinical apparent liver injury reported). 16710643
Twaites B, Wilton LV, Layton D, Shakir SA. Safety of nateglinide as used in general practice in England: results of a prescription-event monitoring study. Acta Diabetol 2007; 44: 233-9. (Postmarketing survey of adverse events occurring in 5950 patients treated with nateglinide by general practitioners in the UK; most common side effects were nausea, malaise, diarrhea, hypoglycemia and dizziness; 3 instances of abnormal liver tests, but no clinically apparent liver injury reported). 17874223
Bolen S, Feldman L, Vassy J, Wilson L, Yeh HC, Marinopoulos S, Wiley C, et al. Systematic review: comparative effectiveness and safety of oral medications for type 2 diabetes mellitus. Ann Intern Med 2007; 147: 386-99. (Systematic review of results from 216 published trials of oral antidiabetic medications; ALT elevations found in <1% of patients receiving metformin, sulfonylureas and metiglinides; "liver failure was so rare that agents could not be compared"). 17638715
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver injury in the US collected from 2004 to 2008, none were attributed to nateglinide or repaglinide). 18955056
Jaiswal S, Mehta R, Musuku M, Tran L, McNamee W Jr. Repaglinide induced acute hepatotoxicity. JNMA J Nepal Med Assoc 2009; 48: 162-4. (78 year old woman developed nausea and abdominal pain 1 month after starting repaglinide [bilirubin 1.6 mg/dL, ALT 582 U/L, Alk P 210 U/L], resolving within a few weeks of stopping). 20387361
Drugs for type 2 diabetes. Treat Guidel Med Lett 2011; 9 (108): 47-54. (Concise overview of the medications used to treat type 2 diabetes; no discussion of hepatotoxicity). 21778966
Drugs for type 2 diabetes. Treat Guidel Med Lett 2014; 12 (139): 17-24. (Concise review of current therapy of type 2 diabetes; no discussion of hepatotoxicity). 24566424
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury in the US collected between 2004 and 2012, 4 [0.5%] cases were attributed to drugs used for diabetes [metformin, glyburide, sitagliptin], but no cases were attributed to nateglinide or repaglinide). 25754159
Drugs for type 2 diabetes. Med Lett Drugs Ther 2017; 59 (1512): 9-18. (Concise summary of the mechanisms of action, efficacy, safety and costs of currently available drugs for type 2 diabetes; mentions that serum enzyme elevations can occur with acarbose therapy and that hepatitis and liver failure have been described with thiazolidinedione and DDP-4 inhibitor therapy; no mention of liver injury from nateglinide or repaglinide). 28076339